# Olmesartan

## OVERVIEW

### Introduction

Olmesartan is an angiotensin II receptor blocker used in the therapy of hypertension. Olmesartan is associated with a low rate of transient serum aminotransferase elevations, but has yet to be linked to instances of acute liver injury.

### Background

Olmesartan (ol" me sar' tan) is an angiotensin II receptor blocker (ARB) used alone or in combination of other agents for therapy of hypertension. Olmesartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II which accounts for its antihypertensive activity. Olmesartan was approved for use in the United States in 2002 and is available in 5, 20 and 40 mg tablets generically under the trade name Benicar. The typical dose of olmesartan in adults in 20 to 40 mg daily in one or two divided doses, and it is used long term. Oral pediatric formulations and suspensions are also available as are fixed combinations with hydrochlorothiazide (Benicar HCT and others) and amlodipine (Azor and others). Side effects are uncommon, but may include headache, dizziness, fatigue, cough, gastrointestinal upset, and fetal toxicity. In addition, olmesartan has been linked to instances of severe sprue-like enteropathy that arises after months or years of therapy and presents with chronic diarrhea, weight loss and abdominal discomfort. Intestinal biopsy shows villous flattening and atrophy, similar to celiac disease. However, symptoms do not improve with a gluten-free diet or corticsteroids, but do resolve promptly upon stopping olmesartan. A similar syndrome has been linked to use of other ARBs including valsartan and losartan.

### Hepatotoxicity

Olmesartan has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. No specific instances of clinically apparent acute liver injury have been reported in association with olmesartan therapy, but like other ARBs it may be associated with rare instances of symptomatic hepatotoxicity. With most ARBs, onset of liver injury is within 1 to 8 weeks of starting therapy and the serum enzyme pattern is typically hepatocellular with an acute hepatitis-like clinical syndrome. In some instances, cholestasis has developed which can be prolonged and relapsing, but ARB therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation. Patients who develop severe enteropathy due to olmesartan may have an accompanying fatty liver disease and steatohepatitis with serum aminotransferrase elevations which, like the diarrhea, resolve with stopping therapy.

Likelihood score: D (Possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations with olmesartan is not known. Olmesartan does not appear to be metabolized by the liver and has minimal drug-drug interactions. The liver injury that accompanies olmesartan-associated enteropathy is probably due to fatty liver disease caused by diarrhea and malnutrition.

### Outcome and Management

The instances of acute liver injury reported with ARB use have been self limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to ARBs, their efficacy has not been shown and their use is best avoided. Patients with olmesartan induced liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of olmesartan are given in the Overview section on the angiotensin II receptor antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Azilsartan, Candesartan, Eprosartan, Irbesartan, Losartan, Telmisartan, Valsartan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Olmesartan – Benicar®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Olmesartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Olmesartan | 144689-24-7 | C24-H26-N6-O3 | Chemical Structure for Olmesartan

## OTHER REFERENCE LINKS

1. Recent References on Olmesartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Olmesartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Olmesartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Olmesartan)